# Pegloticase

## OVERVIEW

### Introduction

Pegloticase is a pegylated, recombinant urate oxidase enzyme that is used to treat patients with chronic refractory and symptomatic gout. Pegloticase has not been associated with serum enzyme elevations during therapy or with instances of clinically apparent liver injury.

### Background

Pegloticase (peg loe’ ti kase) is a recombinant DNA-produced form of the porcine enzyme uricase that metabolizes urate to allantoin, an inert and water soluble purine metabolite that, unlike uric acid, is rapidly cleared by the kidney. Infusions of pegloticase decrease serum uric acid concentrations and can alleviate the symptoms and complications of gout. Pegloticase was approved in the United States in 2010 for use in patients with chronic symptomatic gout who are refractory to conventional therapy with uricourics and xanthine oxidase inhibitors, which should be discontinued before pegloticase is started. It is available as a sterile concentrate of 8 mg in a single use vial under the brand name Kystexxa. The recommended dose 8 mg given intravenously every two weeks. Common side effects of pegloticase include local and systemic infusion reactions, nausea, vomiting, constipation, chest pain and nasopharyngitis. Pegloticase infusions are associated with paradoxical flares of clinical gout during the first 3 months of therapy in up to 80% of patients. Severe adverse reactions may include anaphylaxis (in up to 7% of patients), severe infusion reactions, hemolysis and methemoglobinemia (in patients with G6PD deficiency) and congestive heart failure. Because resistance to pegloticase is associated with antibodies to the molecule and with rise of uric acid levels and initial control, it is recommended that patients be monitored for uric acid levels and that pegloticase be stopped if uric acid levels rise above 6 mg/dL.

### Hepatotoxicity

In large clinical trials, serum enzyme elevations were rare (<1%) during pegloticase therapy and no more common than with placebo. Since licensure and its more wide scale, there have been no published case reports of hepatotoxicity due to pegloticase and the product label does not list liver injury as an adverse event. Thus, liver injury due to pegloticase must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Pegloticase is a polypeptide and is metabolized to amino acids by serum and tissue proteases, and is unlikely to have any direct hepatotoxic potential.

Drug Class: Antigout Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pegloticase – Krystexxa®

DRUG CLASS

Antigout Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pegloticase)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Pegloticase | 885051-90-1 | Protein | Complex Polypeptide

## ANNOTATED BIBLIOGRAPHY

References updated: 21 May 2018

Zimmerman HJ. Drugs used to treat gout. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 543-4. (Textbook of hepatotoxicity published in 1999 and before the availability of pegloticase).
Grosser T, Smyth E, FitzGerald GA. Pharmacotherapy of gout. Anti-inflammatory, antipyretic and analgesic agents; pharmacotherapy of gout. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 994-1000. (Textbook of pharmacology and therapeutics).
Sundy JS, Becker MA, Baraf HS, Barkhuizen A, Moreland LW, Huang W, Waltrip RW 2nd, et al.; Pegloticase Phase 2 Study Investigators. Reduction of plasma urate levels following treatment with multiple doses of pegloticase (polyethylene glycol-conjugated uricase) in patients with treatment-failure gout: results of a phase II randomized study. Arthritis Rheum 2008; 58: 2882-91. (Among 41 patients with severe, refractory gout treated with pegloticase in four dose regimens, adverse reactions included flares of gout and infusion reactions). 18759308
Sundy JS, Baraf HS, Yood RA, Edwards NL, Gutierrez-Urena SR, Treadwell EL, Vázquez-Mellado J, et al. Efficacy and tolerability of pegloticase for the treatment of chronic gout in patients refractory to conventional treatment: two randomized controlled trials. JAMA 2011; 306: 711-20. (Among 225 patients with severe gout treated with pegloticase [8 mg every 2 or 4 weeks] or placebo for 6 months, a decrease in plasma uric acid levels to less than 6 mg/dL was achieved in 35-42% on pegloticase compared to 0% on placebo, and common adverse events were gout flares, infusion reactions, nausea, headache, pruritus and confusion; no mention of ALT elevations or hepatotoxicity). 21846852
Pegloticase (krystexxa) for treatment of refractory gout. Med Lett Drugs Ther 2011; 53 (1357): 9-10. (Concise summary of the mechanism of action, pharmacology, clinical efficacy, safety and costs of pegloticase shortly after its approval for use in gout in the US mentions anaphylaxis, infusion reactions and gout flares, but not ALT elevations or hepatotoxicity). 21304442
Becker MA, Baraf HS, Yood RA, Dillon A, Vázquez-Mellado J, Ottery FD, Khanna D, et al. Long-term safety of pegloticase in chronic gout refractory to conventional treatment. Ann Rheum Dis 2013; 72: 1469-74. (Among 149 patients with gout treated with pegloticase infusions every 2 weeks for an average of 25 months, adverse events included gout flares [71%], infusion reactions [44%], arthralgia [20%] and nausea [11%], but clinical chemistry results did not change from baseline). 23144450
Gentry WM, Dotson MP, Williams BS, Hartley M, Stafford KR, Bottorff MB, Gandhi PK. Investigation of pegloticase-associated adverse events from a nationwide reporting system database. Am J Health Syst Pharm 2014; 71: 722-7. (Among 118 adverse events attributed to pegloticase therapy reported to the FDA over a 2 year period, 11 were cases of anaphylaxis and 35 were infusion related reactions; miscellaneous reactions included 2 cases of hepatic failure, 2 hepatocellular injury, 3 hepatotoxicity, 1 liver function test abnormal and 1 transaminase increased; but no specific details given). 24733135
Pegloticase. An excessively dangerous and inadequately evaluated hypouricaemic drug. Prescrire Int 2014; 23: 173-6. (Commentary on the limited efficacy and potential toxicity of pegloticase infusions). 25162087
Geraldino-Pardilla L, Sung D, Xu JZ, Shirazi M, Hod EA, Francis RO. Methaemoglobinaemia and haemolysis following pegloticase infusion for refractory gout in a patient with a falsely negative glucose-6-phosphate dehydrogenase deficiency result. Rheumatology (Oxford) 2014; 53: 2310-1. (38 year old Hispanic man developed severe hemolytic anemia and methemoglobinemia within 48 hours of an infusion of pegloticase for refractory gout, testing demonstrating G6PD deficiency despite reports of a negative assay done before therapy). 25224415
Baraf HS, Yood RA, Ottery FD, Sundy JS, Becker MA. Infusion-related reactions with pegloticase, a recombinant uricase for the treatment of chronic gout refractory to conventional therapy. J Clin Rheumatol 2014; 20: 427-32. (Among 208 patients who received 6389 infusions of pegloticase in 3 studies, 94 [45%] had an infusion reaction with symptoms usually arising during the infusion [chest discomfort, flushing, dyspnea, back pain, sweating, nausea, erythema, urticarial rash, pruritus, muscle spasms and headache], all resolving with stopping the infusion but leading to discontinuation in 31 [15%] patients, but no patient died or required intubation and ventilation). 25417679
Baldo BA. Enzymes approved for human therapy: indications, mechanisms and adverse effects. BioDrugs 2015; 29: 31-55. (Review of the safety and efficacy of enzyme therapy including pegloticase and rasburicase; no mention of ALT elevations or hepatotoxicity). 25648140
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 was attributed to pegloticase or other therapies for gout). 23419359
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, 8 cases were attributed to drugs used for gout [allopurinol in 7 and febuxostat in 1], but no cases were attributed to pegloticase or rasburicase). 25754159
Wilson FP, Berns JS. Tumor lysis syndrome: new challenges and recent advances. Adv Chronic Kidney Dis 2014; 21: 18-26. (Review of the clinical features and epidemiology of tumor lysis syndrome which is most common during chemotherapy of hematologic malignancies, but can occur during therapy of solid tumors as well as spontaneously without chemotherapy). 24359983
Guttmann A, Krasnokutsky S, Pillinger MH, Berhanu A. Pegloticase in gout treatment - safety issues, latest evidence and clinical considerations. Ther Adv Drug Saf 2017; 8: 379-88. (Careful review of the clinical features and epidemiology of gout and efficacy and safety of pegloticase, common side effects being a flare of gout [71-85%], infusion reactions [26-42%], headache [9-11%], nausea [7-12%] and cardiovascular events [2-7%]; no mention of ALT elevations or hepatotoxicity). 29204266

## OTHER REFERENCE LINKS

1. Recent References on Pegloticase: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pegloticase/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Pegloticase: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pegloticase)